# Alogliptin

## OVERVIEW

### Introduction

Alogliptin is a dipeptidyl peptidase-4 (DPP-4) inhibitor which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other oral hypoglycemic agents. Alogliptin has been reported to cause liver injury, but the characteristics and details of the injury have not been defined in the published literature.

### Background

Alogliptin (al" oh glip' tin) is an inhibitor of dipeptidyl peptidase-4, which is the major enzyme responsible for the degradation of glucagon-like peptide-1 (GLP-1), an important gastrointestinal hormone (incretin) that increases glucose dependent insulin secretion by the pancreas. By prolonging the effect of GLP-1, alogliptin increases insulin levels and lowers blood glucose and helps in glycemic control in patients with type 2 diabetes. Alogliptin was approved for use in the United States in 2013 and was the fourth DPP-4 inhibitor introduced into clinical practice. The current indications are for management of glycemic control in type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents or insulin. Alogliptin is available in tablets of 6.25, 12.5 and 25 mg under the brand name Nesina and in fixed combinations with metformin (12.5/500 mg and 12.5/1000 mg) under the name Kazano and with pioglitazone (various dose combinations) under the name Oseni. The typical dose of alogliptin in adults is 25 mg once daily. Adverse reactions to alogliptin are not common, but may include headache, nausea, rash and hypersensitivity reactions. Hypoglycemia is uncommon with alogliptin alone (<1%), but occurs in higher rates when it is combined with other oral hypoglycemic agents. Alogliptin has also been linked to rare instances of acute pancreatitis that can be severe and even fatal.

### Hepatotoxicity

Liver injury due to alogliptin is rare. In large clinical trials, serum enzyme elevations were uncommon (1% to 3%) and no greater than with comparator arms or placebo. In these studies, no instances of clinically apparent liver injury with jaundice were reported. Since licensure, instances of serum enzyme elevations and acute hepatitis including acute liver failure attributed to alogliptin have been reported to the FDA and the sponsor. These cases have not been reported in the literature and the clinical features have not been defined. Cases of clinically apparent acute liver injury have been reported with other DPP-4 inhibitors such as sitagliptin and saxagliptin. The latency to onset was typically within 2 to 12 weeks of starting and the pattern of liver enzyme elevations was usually hepatocellular. Immunoallergic features were often present. Most cases were self-limited in course and rapidly reversed once the medication was stopped.

Likelihood score: E* (unproven but suspected cause of acute, idiosyncratic liver injury).

### Mechanism of Injury

The cause of liver injury during alogliptin or other DPP-4 inhibitor therapy is not known. Alogliptin is mostly excreted unchanged and only a small proportion (<10%) is metabolized in the liver. Alogliptin has minimal drug-drug interactions.

### Outcome and Management

The instances of liver injury associated with the DPP-4 inhibitors have ranged from mild self-limited serum enzyme elevations to clinically apparent hepatitis and acute liver failure. However, the details of cases with liver injury have not been published. Routine monitoring of serum aminotransferase levels is not recommended but prompt testing for liver test abnormalities is recommended for patients reporting symptoms that may indicate liver injury. The similarity in chemical structure among the DPP-4 inhibitors suggests that there may be cross sensitivity to hepatic injury among the different agents, but this has not been reported. However, the other common antidiabetic medications in use should be tolerated without increased risk of liver injury.

References regarding the hepatotoxicity and safety of the DPP-4 inhibitors are given in the Overview section of DPP-4 Inhibitors (updated 03 January 2018).

Drug Class: Antidiabetic Agents, Incretin-Based Drugs

Other Drugs in the Subclass, Dipeptidyl Peptidase-4 (DPP-4) Inhibitors: Linagliptin, Saxagliptin, Sitagliptin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alogliptin – Nesina®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Alogliptin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alogliptin | 850649-62-6 | C18-H21-N5-O2.C7-H6-O2 | Alogliptin chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Alogliptin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Alogliptin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Alogliptin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alogliptin)